# Acetylcysteine

## OVERVIEW

### Introduction

Acetylcysteine, also known as N-acetylcysteine (NAC), is a modified amino acid that is used as an antidote for acetaminophen overdose to prevent hepatic injury. Acetylcysteine is a hepatoprotective agent and has not been linked to significant serum enzyme elevations during therapy or to instances of clinically apparent acute liver injury.

### Background

Acetylcysteine (a seet" il sis' teen) is a modified amino acid that is used to reverse the toxic effects of acetaminophen overdose and prevent acute liver failure. The amino acid cysteine has a thiol side chain that can undergo redox reactions and thus has antioxidant activity. Importantly, cysteine is required for synthesis of glutathione (a tripeptide of cysteine, glycine and glutamic acid) that is an essential intracellular antioxidant, providing protection against free radicals and other intracellular toxins including intermediates of drug metabolism. Cysteine itself has a disagreeable odor and taste, while acetylated cysteine is more palatable and maintains the ability to support glutathione synthesis. Glutathione can become depleted in patients with malnutrition, chronic debilitating illnesses and chronic alcoholism, and becomes acutely depleted in patients with acetaminophen overdose leading to formation of toxic adducts of acetaminophen metabolites with essential intracellular molecules. Restoration of glutathione stores ameliorates the cell injury from acetaminophen. In multiple clinical trials, administration of acetylcysteine (also referred to as N-acetylcysteine or NAC) within 10 hours of an acetaminophen overdose effectively prevented serious liver injury. Subsequent studies suggested that administration even after 10 hours was partially effective and may also be beneficial in other, non-acetaminophen causes of acute liver failure, including drug induced liver injury. Acetylcysteine also has mucolytic activity and was initially approved for use in humans in 1963 as Mucomyst, a solution for inhalation that helps to emulsify respiratory secretions in patients with pulmonary infections or chronic bronchitis. An oral form of acetylcysteine was approved for use as an acetaminophen antidote in 1978, and an intravenous formulation in 2004. Acetylcysteine is available as effervescent tablets of 500 and 2500 mg (Cetylev) for oral use and as a solution for injection in single dose vials of 200 mg/mL (Acetadote). The dose of acetylcysteine should be calculated based upon body weight and estimated time and acetaminophen ingestion. A nomogram (Rumack-Matthew Nomogram) to calculate the likelihood of liver injury form acetaminophen is available that plots acetaminophen plasma concentrations against time after ingestion that the sample was taken. It is typically given as a loading dose, followed by maintenance dosing every 4 hours for several days. Dosing recommendations are available in the product label and from the U.S. National Poison Center: 1-800-222-1222. Side effects are generally dose related and can include disagreeable taste, diarrhea, nausea and vomiting from the oral formulation and mild-to-moderate hypersensitivity reactions (urticaria, rash, angioedema, wheezing) from the intravenous form. Hypersensitivity reactions can generally be treated satisfactorily with antihistamines.

### Hepatotoxicity

Acetylcysteine is a simple modified amino acid and appears to be hepatoprotective. In the many studies of acetylcysteine use with acetaminophen overdose as well as with other conditions such as contrast media nephropathy, pulmonary fibrosis, cystic fibrosis and ulcerative colitis, it has not been associated with serum enzyme elevations during therapy or with episodes of clinically apparent liver injury. Since approval of the oral and intravenous forms of acetylcysteine, there have been no published reports of hepatotoxicity and the product label does not mention liver injury as an adverse event. Indeed, acetylcysteine may be beneficial in treating liver diseases in general, although its current indications are limited to acetaminophen overdose or acetaminophen related acute liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which acetylcysteine might cause serum aminotransferase elevations or liver injury is not known. It is a modified form of cysteine and is likely metabolized by many cells.

Drug Class: Antidotes, Toxicological Emergency

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acetylcysteine – Generic, Acetadote®, Cetylev®

DRUG CLASS

Antidotes, Toxicological Emergency

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acetylcysteine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acetylcysteine | 616-91-1 | C5-H9-N-O3-S | Acetylcysteine chemical structure
Cysteine | 52-90-4 | C3-H7-N-O2-S | Acetylcysteine chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 07 November 2016

Abbreviations: NAC, N-acetylcysteine

Zimmerman HJ. Acetaminophen toxicity. Syndromes of environmental hepatotoxicity. In, Zimmerman, HJ. Hepatotoxicity. The adverse effects of drugs and other chemicals upon the liver. 2nd edition. Philadelphia: Lippincott, 1999. pp 337-46. (Textbook of drug induced liver injury published in 1999; mentions that treatment with acetylcysteine within 16 hours of an overdose of acetaminophen can minimize hepatic injury and prevent fatalities).
Prescott LF, Illingworth RN, Critchley JA, Stewart MJ, Adam RD, Proudfoot AT. Intravenous N-acetylcysteine: the treatment of choice for paracetamol poisoning. Br Med J 1979; 2 (6198): 1097-100. (Among 100 patients with acetaminophen overdose treated with intravenous NAC, none of 62 treated within 10 hours died compared to 2 of 38 [5%] treated later and 3 of 57 [5%] historical controls given supportive treatment only; “acetylcysteine did not produce any obvious side effects”). 519312
Oh TE, Shenfield GM. Intravenous N-acetylcysteine for paracetamol poisoning. Med J Aust 1980 Jun 28; 1 (13): 664-5. (Among 11 patients with acetaminophen overdose given NAC [Mucomyst, 20% solution] intravenously, none developed liver injury and none had any adverse side effects). 7421628
Rumack BH, Peterson RC, Koch GG, Amara IA. Acetaminophen overdose. 662 cases with evaluation of oral acetylcysteine treatment. Arch Intern Med 1981; 141(3 Spec No): 380-5. (Among 662 patients with acetaminophen overdose in a national open-clinic study, no deaths occurred if oral N-acetylcysteine [NAC] was given within 24 hours; among those with toxic levels, AST elevations above 1000 U/L occurred in 7% given NAC within 10 hours, 29% at 10-16 hours and 62% at 16-24 hours). 7469629
Miller LF, Rumack BH. Clinical safety of high oral doses of acetylcysteine. Semin Oncol 1983; 10 (1 Suppl 1): 76-85. (Among 1329 patients with acetaminophen overdose treated with oral NAC using recommended loading and maintenance doses [up to 30 g daily], diarrhea was common [44%] as was nausea and vomiting [35%], but the role of NAC vs the underlying acetaminophen injury was often difficult to assess). 6340205
Smilkstein MJ, Knapp GL, Kulig KW, Rumack BH. Efficacy of oral N-acetylcysteine in the treatment of acetaminophen overdose. Analysis of the national multicenter study (1976 to 1985). N Engl J Med 1988; 319: 1557-62. (Results of multicenter trial of 2540 patients with acetaminophen overdose given oral NAC: 28 deaths were due to acetaminophen, but none among those given NAC less than 16 hours after overdose; rate of ALT elevations above 1000 U/L was 6% if NAC was given within 10 hours and 26% if between 10 and 24 hours after ingestion). 3059186
Smilkstein MJ, Bronstein AC, Linden C, Augenstein WL, Kulig KW, Rumack BH. Acetaminophen overdose: a 48-hour intravenous N-acetylcysteine treatment protocol. Ann Emerg Med 1991; 20: 1058-63. (Among 179 patients with acute acetaminophen overdose treated with a 48-hour regimen of intravenous NAC, efficacy was similar to that of longer regimens, and 32 [18%] had side effects that were mostly transient flushing and rash). 1928874
Bailey B, McGuigan MA. Management of anaphylactoid reactions to intravenous N-acetylcysteine. Ann Emerg Med 1998; 31: 710-5. (Among 60 patients with acetaminophen overdose treated with intravenous NAC, 23% had an anaphylactoid reaction [flushing, rash, angioedema, wheezing], but all responded to antihistamines and were able to restart therapy, which was the basis for a prospective analysis of management guidelines). 9624310
Webb JG, Pate GE, Humphries KH, Buller CE, Shalansky S, Al Shamari A, Sutander A, et al. A randomized controlled trial of intravenous N-acetylcysteine for the prevention of contrast-induced nephropathy after cardiac catheterization: lack of effect. Am Heart J 2004; 148: 422-9. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2015389228) (Among 487 patients with renal dysfunction undergoing cardiac catheterization and intravenous infusions of contrast who were treated with intravenous NAC [500 mg] or placebo, subsequent rates of renal injury were similar in both groups [23% vs 21%] and mild cutaneous reactions occurred in less than 1% of both groups).
Guijarro LG, Mate J, Gisbert JP, Perez-Calle JL, Marin-Jimenez I, Arriaza E, Olleros T, et al. N-acetyl-L-cysteine combined with mesalamine in the treatment of ulcerative colitis: randomized, placebo-controlled pilot study. World J Gastroenterol 2008; 14: 2851-7. (Among 37 patients with ulcerative colitis treated with mesalamine and either NAC [800 mg daily] or placebo for 4 weeks, side effects were similar in both groups and there were no differences in changes in serum enzyme levels). 18473409
Lee WM, Squires RH Jr, Nyberg SL, Doo E, Hoofnagle JH. Acute liver failure: Summary of a workshop. Hepatology 2008; 47: 1401-15. (Review of the causes, clinical course, complications, management and treatment of acute liver failure). 18318440
Berk M, Copolov D, Dean O, Lu K, Jeavons S, Schapkaitz I, Anderson-Hunt M, et al. N-acetyl cysteine as a glutathione precursor for schizophrenia—a double-blind, randomized, placebo-controlled trial. Biol Psychiatry 2008; 64: 361-8. (Among 140 patients with schizophrenia treated with oral NAC [1 g twice daily] or placebo for 24 weeks “there were no significant effects of NAC on safety parameters or reported adverse events”). 18436195
Kortsalioudaki C, Taylor RM, Cheeseman P, Bansal S, Mieli-Vergani G, Dhawan A. Safety and efficacy of N-acetylcysteine in children with non-acetaminophen-induced acute liver failure. Liver Transpl 2008; 14: 25-30. (Among 57 children with non-acetaminophen related acute liver failure treated with NAC, survival with the native liver was 48%, which was higher than the historical control rate [22%]; adverse events [11%] included rash, arrhythmias, edema and bronchospasm). 18161828
Dauletbaev N, Fischer P, Aulbach B, Gross J, Kusche W, Thyroff-Friesinger U, Wagner TO, et al. A phase II study on safety and efficacy of high-dose N-acetylcysteine in patients with cystic fibrosis. Eur J Med Res 2009; 14: 352-8. (Among 21 patients with cystic fibrosis treated with low- or high-dose oral NAC [700 or 2800 mg daily] pulmonary function did not change in either group and adverse events were generally mild; no serious adverse event was attributed to NAC). 19666395
Lee WM, Hynan LS, Rossaro L, Fontana RJ, Stravitz RT, Larson AM, Davern TJ 2nd, et al.; Acute Liver Failure Study Group. Intravenous N-acetylcysteine improves transplant-free survival in early stage non-acetaminophen acute liver failure. Gastroenterology 2009; 137: 856-64, 864. (Among 173 adults with non-acetaminophen related acute liver failure treated with intravenous NAC or placebo for 72 hours, transplant free survival was better with NAC therapy [40% vs 27%] and adverse event rates were similar except for nausea and vomiting [14% vs 4%]). 19524577
Whyte AJ, Kehrl T, Brooks DE, Katz KD, Sokolowski D. Safety and effectiveness of acetadote for acetaminophen toxicity. J Emerg Med 2010; 39: 607-11. (Among 64 patients with acetaminophen overdose treated with intravenous NAC, 6 [9%] had an anaphylactoid reaction, but all recovered fully and were able to restart NAC). 19022608
Bebarta VS, Kao L, Froberg B, Clark RF, Lavonas E, Qi M, Delgado J, et al. A multicenter comparison of the safety of oral versus intravenous acetylcysteine for treatment of acetaminophen overdose. Clin Toxicol (Phila) 2010; 48: 424-30. (Among 503 subjects with acetaminophen overdose treated at 11 medical centers with oral or intravenous NAC or both for 20 to 80 hours, a retrospective analysis showed that 90% survived without liver transplantation, nausea and vomiting being common adverse events with oral and anaphylactoid reactions with intravenous therapy [6%]). 20524832
Lai ZW, Hanczko R, Bonilla E, Caza TN, Clair B, Bartos A, Miklossy G, et al. N-acetylcysteine reduces disease activity by blocking mammalian target of rapamycin in T cells from systemic lupus erythematosus patients: a randomized, double-blind, placebo-controlled trial. Arthritis Rheum 2012; 64: 2937-46. (Among 36 patients with systemic lupus treated with oral NAC [1.2, 2.4 or 4.8 g daily] or placebo for 3 months, the higher doses of NAC were associated with improvement in symptom scores but also with more nausea). 22549432
Idiopathic Pulmonary Fibrosis Clinical Research Network; Martinez FJ, de Andrade JA, Anstrom KJ, King TE Jr, Raghu G. Randomized trial of acetylcysteine in idiopathic pulmonary fibrosis. N Engl J Med 2014; 370: 2093-101 (Among 264 patients with pulmonary fibrosis treated with oral NAC [600 mg three times daily] or placebo for 60 weeks, there were no differences in pulmonary function or rates of exacerbation or death and rates of adverse events were similar; no mention of ALT elevations or hepatotoxicity). 24836309
Johnson K, McEvoy CE, Naqvi S, Wendt C, Reilkoff RA, Kunisaki KM, Wetherbee EE, et al. High-dose oral N-acetylcysteine fails to improve respiratory health status in patients with chronic obstructive pulmonary disease and chronic bronchitis: a randomized, placebo-controlled trial. Int J Chron Obstruct Pulmon Dis 2016; 11: 799-807. (Among 51 patients with chronic obstructive pulmonary disease treated with oral NAC [1.8 g daily] or placebo for 8 weeks, there were no changes in respiratory status and side effects were generally mild and there were no significant changes in ALT from baseline). 27143871
Grendar J, Ouellet JF, McKay A, Sutherland FR, Bathe OF, Ball CG, Dixon E. Effect of N-acetylcysteine on liver recovery after resection: A randomized clinical trial. J Surg Oncol 2016; 114: 446-50. (Among 206 patients undergoing hepatic resection who were treated with postoperative intravenous NAC or not for 4 days, complications were more common with NAC [delirium, creatinine, hemoglobin], but not ALT or bilirubin levels). 27302646
Ahmadi F, Abbaszadeh M, Razeghi E, Maziar S, Khoidaki SD, Najafi MT, Lessan-Pezeshki M. Effectiveness of N-acetylcysteine for preserving residual renal function in patients undergoing maintenance hemodialysis: multicenter randomized clinical trial. Clin Exp Nephrol 2017; 21(2): 342-9. (Among 54 Iranian patients on hemodialysis for chronic renal failure who were treated with NAC [1.2 g twice daily] or no treatment, renal function improved more with NAC treatment, but 3 patients stopped therapy early because of side effects [urticaria, gastrointestinal discomfort]; no mention of ALT levels or hepatotoxicity). 27206513

## OTHER REFERENCE LINKS

1. Recent References on Acetylcysteine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Acetylcysteine+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Acetylcysteine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acetylcysteine)